# Orlistat

## OVERVIEW

### Introduction

Orlistat is an inhibitor of pancreatic and gastric lipase and a commonly used weight loss agent that is available both by prescription and over-the-counter. Orlistat has been linked to rare instances of acute liver injury, some of which have been severe.

### Background

Orlistat (or' li stat) is a tetrahydrolipstatin, a saturated derivative of lipstatin which is a potent natural inhibitor of gastric and pancreatic lipase. Orlistat when taken with meals inhibits the digestion of dietary fats and prevents their absorption, thus reducing caloric intake. When used in conjunction with caloric restriction and exercise, orlistat improves weight loss. Orlistat was approved for use in the United States in 1999, and an over-the-counter formulation of the drug was approved in 2007. Orlistat is available by prescription as capsules of 120 mg in generic forms and under the trade name Xenical and over-the-counter as capsules of 60 mg under the trade name Alli. The usual dose is one capsule three times daily before meals. Orlistat is minimally, if at all, absorbed, and its side effects are largely due to its effect on fat absorption including abdominal discomfort, bloating, gaseousness, diarrhea, fecal leakage and steatorrhea (oily stools and fat-soluble vitamin malabsorption). Symptoms are particularly prominent if orlistat is given before a high fat meal and they tend to lessen with more prolonged therapy (perhaps due to its adverse effects, leading to a lower fat diet).

### Hepatotoxicity

Orlistat acts my binding pancreatic and gastric lipase in the intestinal tract. Systemic absorption is not needed for its effect. Indeed, little of orally administered orlistat is absorbed (1% to 3%) and plasma levels are usually undetectable or less than 4 ng/mL (too little to inhibit serum lipase activities). Thus, systemic side effects of orlistat were not expected. In large clinical trials, serum liver test abnormalities were no more common with orlistat than with placebo therapy. Nevertheless, there have been several case reports of clinically apparent acute liver injury attributed to orlistat and in 2010 the FDA announced safety concerns regarding hepatotoxicity. The onset of injury in published cases was between 2 to 12 weeks of starting orlistat. The usual pattern of serum enzyme elevations was hepatocellular and some cases were severe with signs of hepatic failure and progression to death or need for liver transplantation. Features of hypersensitivity were not prominent and autoimmune markers were absent. None of the published cases included results of rechallenge. Thus, despite the number of published case reports, the hepatotoxicity of orlistat remains controversial and far from proven.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which orlistat causes liver injury is not known. Because only small amounts of orlistat are absorbed, hypersensitivity is likely the mechanism by which the liver is damaged. However, typical features of hypersensitivity have not been prominent in case reports.

### Outcome and Management

The liver injury that occurs during orlistat therapy ranges in severity from minor serum aminotransferase elevations to acute symptomatic hepatitis to severe acute liver failure that can be fatal or require emergency liver transplantation. There is no known therapy for orlistat induced liver injury. Recurrence of injury upon rechallenge has not been reported, but patients with clinically apparent liver injury attributed to orlistat should be instructed to avoid future exposures including to the widely available over-the-counter forms.

Drug Class: Weight Loss Agents

## CASE REPORT

### Case 1. Acute liver failure in a patient on orlistat for weight loss.(1)

A 35 year old woman developed abnormal liver tests 3 weeks after starting orlistat for weight loss. Initially, she was asymptomatic. She had no history of alcohol abuse or risk factors for viral hepatitis and was taking no other medications. She had been treated with other weight loss agents in the past, and serum enzymes had been tested on several occasions and were always normal. Physical examination was normal without jaundice, fever, rash or abdominal tenderness. Orlistat was discontinued. Two weeks later she became symptomatic with jaundice and serum enzymes had risen markedly (Table). She was admitted and monitored closely. Tests for hepatitis A, B and C were negative and serum autoantibodies were not present. Her prothrombin index fell progressively and she developed hyponatremia, ascites and encephalopathy. She referred for and underwent successful liver transplantation 4 weeks after onset. The liver explant showed massive hepatic necrosis.

#### Key Points

Medication: | Orlistat (120 mg three times daily)
Pattern: | Hepatocellular
Severity: | 5+ (acute liver failure and transplantation)
Latency: | 3 weeks
Recovery: | None
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
Pre | | Normal | Normal
| | Orlistat (120 mg three times daily) given for 3 weeks
3 weeks | 0 | 1016 | 215 | 1.0
5 weeks | 2 weeks | 1548 | | 5.1 | Prothrombin index: 45%
6 weeks | 3 weeks | 1500 | | 9.5 | Prothrombin index: 30%
7 weeks | 4 weeks | | | | Prothrombin index: 17%
7 weeks | 4 weeks | Emergency liver transplantation
Normal Values | | <40 | <45 | <1.2

#### Comment

This initial report of severe hepatotoxicity from orlistat was met with some skepticism despite the relationship between time of starting the medication and onset of injury and the absence of other potential causes. Against the diagnosis of orlistat induced liver injury was the lack of improvement with stopping. However, the only other alternative diagnosis is idiopathic acute liver failure, another diagnosis of exclusion. The rapidity of onset and severe course suggest hypersensitivity as a cause, but there was no rash or fever and no mention of eosinophilia. Subsequently, several other similar cases attributed to orlistat use have been described.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Orlistat – Generic, Alli®, Xenical®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=orlistat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Orlistat | 96829-58-2 | C29-H53-N-O5

## CITED REFERENCE

1 Montero JL, Muntané J, Fraga E, Delgado M, Costán G, Serrano M, et al. (2001). Orlistat associated subacute hepatic failure. J Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity published in 1999; orlistat is not discussed).
Zhi J, Melia AT, Eggers H, Joly R, Patel IH. (1995). Review of limited systemic absorption of orlistat, a lipase inhibitor, in healthy human volunteers. J Clin Pharmacol. (Pharmacokinetic studies found low levels of orlistat [<4 ng/mL] in plasma of healthy volunteers after oral administration; 97-100% of orally administered radiolabeled orlistat is recovered in the feces, 0-3% in urine).
Sjöström L, Rissanen A, Andersen T, Boldrin M, Golay A, Koppeschaar HP, Krempf M. (1998). Randomised placebo-controlled trial of orlistat for weight loss and prevention of weight regain in obese patients. European Multicentre Orlistat Study Group. Lancet. (Controlled trial of orlistat vs placebo in 688 obese patients found increased weight loss in orlistat treated patients at one and two years; “no clinically or statistically significant changes in the mean values of any laboratory measurements during the study, and the frequency of laboratory abnormalities was evenly distributed…”).
Zhi J, Mulligan TE, Hauptman JB. (1999). Long-term systemic exposure of orlistat, a lipase inhibitor, and its metabolites in obese patients. J Clin Pharmacol. (Monitoring plasma orlistat levels in 5 clinical studies found detectable levels in 29% of patients receiving 120 mg thrice daily, but all levels were less than 5 ng/mL).
Finer N, James WP, Kopelman PG, Lean ME, Williams G. (2000). One-year treatment of obesity: a randomized, double-blind, placebo-controlled, multicentre study of orlistat, a gastrointestinal lipase inhibitor. Int J Obes Relat Metab Disord. (Controlled trial of orlistat vs placebo for one year in 228 obese patients found greater weight loss with orlistat [8.5% vs 5.4%]; side effects were similar in the two groups, except for gastrointestinal effects; no mention of ALT elevations or liver related adverse events).
Montero JL, Muntané J, Fraga E, Delgado M, Costán G, Serrano M, Padillo J, et al. (2001). Orlistat associated subacute hepatic failure. J Hepatol. (35 year old woman developed elevated liver enzymes 3 weeks after starting orlistat [bilirubin 1 mg/dL, ALT 1016 U/L], with progressive worsening, jaundice and coagulopathy undergoing liver transplantation one month later; the explant showed massive necrosis: Case 1).
Kim DH, Lee EH, Hwang JC, Jeung JH, Kim DY, Cheong JY, Cho SW, Kim YB. (2002). Taehan Kan Hakhoe Chi. (33 year old woman developed jaundice without fever or rash 2 months after starting orlistat [bilirubin 20.1 mg/dL; ALT 251 U/L, Alk P 110 U/L], ultimately being treated with prednisone and hospitalized for 24 days, but with subsequent resolution).
Haddock CK, Poston WS, Dill PL, Foreyt JP, Ericsson M. (2002). Pharmacotherapy for obesity: a quantitative analysis of four decades of published randomized clinical trials. Int J Obes Relat Metab Disord. (Metaanalysis of published studies of antiobesity medications; orlistat has been studied in 6 controlled trials published between 1995-99; no discussion of side effects).
Kelley DE, Bray GA, Pi-Sunyer FX, Klein S, Hill J, Miles J, Hollander P. (2002). Clinical efficacy of orlistat therapy in overweight and obese patients with insulin-treated type 2 diabetes: A 1-year randomized controlled trial. Diabetes Care. (Control trial of orlistat vs placebo in 550 obese patients with diabetes found greater weight loss with orlistat [3.9% vs 1.3%]; gastrointestinal side effects were frequent, but “the incidence of adverse events related to other organ systems was similar in placebo- and orlistat-treated subjects”).
Sabuncu T, Nazligul Y, Karaoglanoglu M, Ucar E, Kilic FB. (2003). The effects of sibutramine and orlistat on the ultrasonographic findings, insulin resistance and liver enzyme levels in obese patients with non-alcoholic steatohepatitis. Rom J Gastroenterol. (Trial of 6-month course of sibutramine [n=13] vs orlistat [n=12] in 25 obese patients with nonalcoholic steatohepatitis; both agents were associated with weight loss and improvements in hepatic fat and ALT levels [79 to 32 U/L], but slight increase in Alk P [~175 to ~196 U/L]; no patient stopped therapy because of side effects).
Halpern A, Mancini MC, Suplicy H, Zanella MT, Repetto G, Gross J, Jadzinsky M, et al. (2003). Latin-American trial of orlistat for weight loss and improvement in glycaemic profile in obese diabetic patients. Diabetes Obes Metab. (Controlled trial of orlistat vs placebo in 338 obese patients found greater weight loss at 24 weeks [4.7% vs 3.0%]; no liver related severe adverse events occurred, and “Non-clinically or statistically significant abnormalities in laboratory measurements occurred sporadically in both treatment groups”, ALT and AST being measured every 8 weeks).
Torgerson JS, Hauptman J, Boldrin MN, Sjöström L. (2004). XENical in the prevention of diabetes in obese subjects (XENDOS) study: a randomized study of orlistat as an adjunct to lifestyle changes for the prevention of type 2 diabetes in obese patients. Diabetes Care. (4 year controlled trial of orlistat vs placebo in 3,305 obese patients without diabetes found greater sustained weight loss with orlistat [5.8 vs 3.0 kg]; gastrointestinal side effects were more common with orlistat, but serious adverse events were similar; no mention of ALT elevations or liver related events).
Li Z, Maglione M, Tu W, Mojica W, Arterburn D, Shugarman LR, Hilton L, et al. (2005). Meta-analysis: pharmacologic treatment of obesity. Ann Intern Med. (Systematic review of efficacy and safety of medications for obesity; in 29 published studies, orlistat therapy was associated with a significant, but modest increase in weight loss; side effects included flatulence, bloating, diarrhea, abdominal pain and dyspepsia; no serious adverse events related to drug reported).
Thurairajah PH, Syn WK, Neil DA, Stell D, Haydon G. (2005). Orlistat (Xenical)-induced subacute liver failure. Eur J Gastroenterol Hepatol. (57 year old woman developed jaundice 10 weeks after starting orlistat [bilirubin 8.1 rising to 39 mg/dL, AST 1505 U/L, Alk P 215 U/L], with progressive hepatic failure over next 3 months leading to liver transplantation; explants showing massive necrosis).
Umemura T, Ichigo T, Matsumoto A, Kiyosawa K. (2006). Severe hepatic injury caused by orlistat. Am J Med. (15 year old Thai female took orlistat for 7 days and 7 days later developed nausea and abdominal pain [bilirubin 1.3 mg/dL, ALT 9976 U/L, eosinophils 7%], with resolution within 1 month).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al., Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to orlistat or other agents used for weight loss).
Filippatos TD, Derdemezis CS, Gazi IF, Nakou ES, Mikhailidis DP, Elisaf MS. (2008). Orlistat-associated adverse effects and drug interactions: a critical review. Drug Saf. (Review of the safety and adverse side effects of orlistat mentions that at least five cases of severe acute liver injury have been reported in patients taking orlistat).
FDA. Information on Orlistat. 2010. Available at: https://www.fda.gov/drugs/postmarket-drug-safety-information-patients-and-providers/fda-drug-safety-communication-completed-safety-review-xenicalalli-orlistat-and-severe-liver-injury. (Safety review of orlistat and severe liver injury mentions that there were no signals of severe liver injury in the preclinical and clinical trials of orlistat, but that 12 cases of severe liver injury were reported after its marketing; "At this time, a cause and effect relationship of severe liver injury with orlistat use has not been established").
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to orlistat or other weight loss agents).
Athyros VG, Giouleme O, Ganotakis ES, Elisaf M, Tziomalos K, Vassiliadis T, Liberopoulos EN, Theocharidou E, Karagiannis A, Mikhailidis DP. (2011). Safety and impact on cardiovascular events of long-term multifactorial treatment in patients with metabolic syndrome and abnormal liver function tests: a post hoc analysis of the randomised ATTEMPT study. Arch Med Sci. (Open label study of multifactorial interventions [which included orlistat for obesity] enrolled 326 patients with ALT elevations and ultrasound evidence of fatty liver; ALT levels improved in most patients and "there were no major side-effects").
Jain SS, Ramanand SJ, Ramanand JB, Akat PB, Patwardhan MH, Joshi SR. (2011). Evaluation of efficacy and safety of orlistat in obese patients. Indian J Endocrinol Metab. (Controlled trial of orlistat vs placebo for 24 weeks in 80 obese patients; serum ALT and AST values did not change between the beginning and the end of the study).
(2011). Diet, drugs and surgery for weight loss. Treat Guidel Med Lett. (Concise summary of treatment recommendations for weight loss mentions that orlistat is modestly effective in increasing weight loss and rare cases of severe liver injury have been reported with its use).
Morris M, Lane P, Lee K, Parks D. (2012). An integrated analysis of liver safety data from orlistat clinical trials. Obes Facts. (Analysis of ALT elevations in controlled trials of orlistat in over 10,000 subjects, found slightly higher rates of ALT elevations with orlistat [7.4%] than placebo [6.9%], perhaps due to a greater frequency of measurement and lower drop-out rates with orlistat; combined elevations of ALT and bilirubin were rare [n=17] and rates were lower in orlistat [0.13%] than placebo [0.23%] treated subjects).
Derosa G, Maffioli P. (2012). Anti-obesity drugs: a review about their effects and their safety. Expert Opin Drug Saf. (Review of safety and efficacy of weight loss agents in recent use; no discussion of hepatotoxicity or ALT elevations, but concludes that "Orlistat is a good choice for the treatment of obesity, because of its safety...").
Kang JG, Park CY. (2012). Anti-obesity drugs: a review about their effects and safety. Diabetes Metab J. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions previous FDA review of liver injury and orlistat which identified 32 reports of severe liver injury including 6 cases of acute liver failure).
Ara R, Blake L, Gray L, Hernández M, Crowther M, Dunkley A, Warren F, et al. (2012). What is the clinical effectiveness and cost-effectiveness of using drugs in treating obese patients in primary care? A systematic review. Health Technol Assess. (Systematic review of the literature on weight loss agents analyzed 94 studies involving 24,808 subjects and concluded that all active treatments were effective in reducing weight and BMI and all were cost effective; no discussion of hepatotoxicity).
Douglas IJ, Langham J, Bhaskaran K, Brauer R, Smeeth L. (2013). Orlistat and the risk of acute liver injury: self controlled case series study in UK Clinical Practice Research Datalink. BMJ. (Among 94,695 patients receiving orlistat who were registered in the UK Clinical Practice Research Database, there was no evidence of an increased risk of liver injury during treatment).
Wilding J. (2013). Orlistat: should we worry about liver inflammation?. BMJ. (Editorial in response to Douglas [2013] mentions that there have been 21 reports of severe liver injury attributed to orlistat, but that more than 50 million persons worldwide have been exposed to the agent).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (Population based prospective analysis of cases of drug induced liver injury seen over a two year period in Iceland identified 96 cases, none of which were attributed to orlistat or other weight loss agents).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996-2012 identified 176 cases, none of which were attributed to orlistat or other weight loss agents).
Yanovski SZ, Yanovski JA. (2014). Long-term drug treatment for obesity: a systematic and clinical review. JAMA. (Systematic review of the literature on the efficacy of long term use of drugs for obesity that were FDA approved [at the time of the analysis] mentions that phentermine, diethylpropion and phendimetrazine are approved for short term use only, but that orlistat, lorcaserin and phentermine/topiramate are approved for long term use although their efficacy is modest; no discussion of hepatotoxicity).
Halpern B, Halpern A. (2015). Safety assessment of FDA-approved (orlistat and lorcaserin) anti-obesity medications. Expert Opin Drug Saf. (Review of the safety of orlistat and lorcaserin discusses the issue of hepatotoxicity concludes that “there is no convincing evidence that orlistat is associated with any liver abnormality, despite FDA’s alert, based upon post-marketing surveillance and individual case reports which are subject to several biases”).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none of the cases were attributed to orlistat although in two instances of liver injury considered only possibly due to a medication, orlistat was one of the listed possible causes).
Hodkinson A, Gamble C, Smith CT. Reporting of harms outcomes: a comparison of journal publications with unpublished clinical study reports of orlistat trials. Trials 2016; 17: 207. (Comparison of data on adverse events in publications vs. clinical study reports from the pharmaceutical sponsor from five studies of orlistat found underreporting of serious adverse events in publications, but most were judged to be unrelated and none were episodes of acute liver injury).
Aagaard L, Hallgreen CE, Hansen EH. (2016). Serious adverse events reported for antiobesity medicines: postmarketing experiences from the EU adverse event reporting system EudraVigilance. Int J Obes (Lond). (Analysis of adverse event reports from antiobesity medications to the European pharmacovigilance database [EudraVigilance] between 2007 and 2013 identified 4941 reports detailing 13,957 individual adverse events, 90% serious, 37% attributed to orlistat including 204 hepatobiliary events and 28 deaths; no details provided).
(2018). Diet, drugs, devices, and surgery for weight management. Med Lett Drugs Ther. (Concise review of the medical and surgical therapies for obesity mentions that orlistat is modestly effective in inducing weight loss and that “severe liver injury has been reported rarely, but no cause-and-effect relationship has been established).
Saunders KH, Umashanker D, Igel LI, Kumar RB, Aronne LJ. (2018). Obesity pharmacotherapy. Med Clin North Am. (Review of the pharmacotherapy of obesity focusing upon the 6 most commonly used medications, discusses the common side effects of orlistat including fecal urgency, oily stool and fecal incontinence, but does not discuss hepatotoxicity).
Shirai K, Fujita T, Tanaka M, Fujii Y, Shimomasuda M, Sakai S, Samukawa Y. (2019). Efficacy and safety of lipase inhibitor orlistat in Japanese with excessive visceral fat accumulation: 24-week, double-blind, randomized, placebo-controlled study. Adv Ther. (Among 200 Japanese obese adults treated with orlistat [60 mg] or placebo 3 times daily for 24 weeks, weight loss was greater with orlistat [-2.8% vs -1.2%] and there were no serious adverse events, although 2 patients taking orlistat had liver test abnormalities during treatment [no details provided]).
Khalil H, Ellwood L, Lord H, Fernandez R. (2020). Pharmacological treatment for obesity in adults: an umbrella review. Ann Pharmacother. (An “umbrella” review of systematic reviews of pharmacological therapy of obesity identified 9 reviews on 3 agents [orlistat, liraglutide and naltrexone-bupropion] and concluded that all three were more effective than placebo, but that there was little evidence that one was superior to the others in causing weight loss; only the common minor side effects of orlistat were discussed).

## OTHER REFERENCE LINKS

1 Recent References on Orlistat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Orlistat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Orlistat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Orlistat)